# Pine Bark

## OVERVIEW

### Introduction

Pine bark is an extract from the bark of several species of pine trees (Pinus) used in traditional medicine to treat a wide variety of conditions, most frequently to improve cognition, cardiovascular and metabolic health, arthritis and joint pains, and anxiety. Pine bark is generally recognized as safe and has not been linked to serum enzyme elevations during therapy nor to episodes of clinically apparent liver injury.

### Background

Pine bark is an extract of bark from pine tree species (Pinus) found throughout the Northern and parts of the Southern hemisphere and used for centuries generally for its anti-oxidant and anti-inflammatory activity and its vitamin C content. The most frequently mentioned species of pine used are Northern hemisphere maritime pines such as Pinus pinaster. Pinus radiata from New Zealand and Pinus massoniana from China are also used for making pine bark extracts. Chemical analyses demonstrate multiple constituents in pine bark including unique phenolic acids and flavonoids as well as cellulose, tannins, stilbenes, lignins, carbohydrates, sugars, and multiple minerals and vitamins. Pine bark is particularly rich in polyphenols, catechins, and proanthrocyanidins all of which have anti-oxidant activities and are thought to represent the active ingredients in the botanical product. Purported uses of pine bark include asthma, attention deficit hyperactivity disorder (ADHD), cardiovascular disease, chronic venous insufficiency, diabetes, erectile dysfunction, female sexual dysfunction, mental acuity and concentration, osteoarthritis, osteopenia and traumatic brain injury. While there have been many clinical trials of pine bark for these indications, all have been limited in size and duration of therapy. Most studies have shown only modest changes in clinical symptoms, physical signs, or biologic features, and none have been considered definitive in demonstrating efficacy or safety. Pine bark is available in multiple forms including powders, tablets, capsules, solution, gummies, and teas. The typical dose is 100 to 400 mg daily. Some preparations are purified concentrations of proanthocyanidins from the equivalent of several grams of water extracts of pine bark. A commonly used commercial preparation available in Europe (Pycnogenol®) is a standardized extract of Pinus pinaster with 70% procyanidins that is used in doses of 100 to 200 mg daily. Recently, pine bark has been included in several multi-ingredient dietary supplements where the concentration is not provided. In clinical trials of various preparations and dosages of pine bark there have been no consistently reported adverse effects or reported instances of hypersensitivity. A single report of muscle injury and rhabdomyolysis has been reported recently perhaps associated with a higher-than-recommended dose.

### Hepatotoxicity

Pine bark has not been subjected to large, prospective trials of its safety but is widely described as being well tolerated and without side effects. In small clinical trials of pine bark, there have been no reports of serum aminotransferase or bilirubin elevations or instances of clinically apparent liver injury. Pine bark is not mentioned or listed in large case series or systematic reviews of the literature on herbal and dietary supplement induced liver injury. In a few instances of liver injury attributed to multi-ingredient herbal products, pine bark was listed as one of several herbal components: but typically other well established herbal causes of liver injury were also listed. Thus, there is no evidence that pine bark in typical oral doses or as a component of herbal products or teas causes clinically apparent liver injury in humans.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pine bark has not been linked to serum enzyme elevations during therapy or clinically apparent liver injury. The mechanism by which pine bark might cause liver injury is not known but a large number of components have been identified in Pinus species extracts. The major components responsible for its purported effects include procyanidins, catechins, and phenolic acids.

Drug Class: Herbal and Dietary Supplements

Other names: Maritime pine bark, Pycnogenol®, Flavagenol®.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pine bark – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/pinebarkextract)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | STRUCTURE
Pine Bark | 174882-69-0

## ANNOTATED BIBLIOGRAPHY

References updated: 25 November 2025

Abbreviations: HDS, herbal and dietary supplements; DILI, drug-induced liver injury; ADHD, attention deficit hyperactivity disorder; HbA1c, hemoglobulin A1c; CK, creatine kinase.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not pine bark).
Trebatická J, Kopasová S, Hradecná Z, Cinovský K, Skodácek I, Suba J, Muchová J et al. Treatment of ADHD with French maritime pine bark extract, Pycnogenol. Eur Child Adolesc Psychiatry. 2006;15:329-35.. (Among 61 children with attention deficit hyperactivity disorder [ADHD] treated with pine bark extract [Pycnogenol, 1 mg/kg] or placebo once daily for 4 weeks, scores of concentration and hyperactivity improved slightly on pine bark and returned to baseline levels after stopping while no serious side effects were reported, and liver test results remained normal). 16699814
Yang HM, Liao MF, Zhu SY, Liao MN, Rohdewald P. A randomised, double-blind, placebo-controlled trial on the effect of Pycnogenol on the climacteric syndrome in peri-menopausal women. Acta Obstet Gynecol Scand. 2007;86:978-85.. (Among 200 “peri-menopausal” women [ages 44-55 years] treated with pine bark extract [Pycnogenol 100 mg] or placebo twice daily for 6 months, climacteric symptoms were improved on treatment while “no side effects were reported”, results of ALT and AST tests were not provided). 17653885
Cesarone MR, Belcaro G, Rohdewald P, Pellegrini L, Ledda A, Vinciguerra G, Ricci A, et al. Improvement of signs and symptoms of chronic venous insufficiency and microangiopathy with Pycnogenol: a prospective, controlled study. Phytomedicine. 2010;17:835-9.. (Among 98 adults with symptomatic chronic venous insufficiency treated with pine bark extract [Pycnogenol 50 mg 3 times daily] or stockings only or both for 8 weeks, improvements in symptoms and physical findings were greatest with the combination, and pine bark alone improved features as well, and no side effects were observed and all blood test results “were within the normal range”). 20579863
Drieling RL, Gardner CD, Ma J, Ahn DK, Stafford RS. No beneficial effects of pine bark extract on cardiovascular disease risk factors. Arch Intern Med. 2010;170:1541-7.. (Among 130 adults at increased risk for cardiovascular disease treated with oral pine bark extract [200 mg] or placebo once daily for 12 weeks, there were no differences in changes in blood pressure, or in levels of cholesterol, glucose, insulin, C-reactive protein, or serum ALT or AST between the two groups, and rates of common adverse events [headache, somnolence, insomnia, gastrointestinal upset] were similar). 20876405
Maimoona A, Naeem I, Saddiqe Z, Jameel K. A review on biological, nutraceutical and clinical aspects of French maritime pine bark extract. J Ethnopharmacol. 2011;133:261-77.. (A review of the literature concludes that the “biological, clinical, and nutraceutical significance of pine bark extracts is obvious” and that data from 70 clinical trials of daily doses of 20 to 300 mg daily have shown that it is safe with a low rate of adverse events [2.4%: gastrointestinal discomfort, dizziness, headache and nausea] and no alarming side effects even at high doses). 21044675
Li YY, Feng J, Zhang XL, Cui YY. Pine bark extracts: nutraceutical, pharmacological, and toxicological evaluation. J Pharmacol Exp Ther. 2015;353:9-16.. (Review of the chemistry, pharmacology, and biologic activity of pine bark extracts from Pinus pinaster, radiata and massoniana; no mention of hepatic adverse effects). 25597308
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to pine bark). 19650152
Mei L, Mochizuki M, Hasegawa N. Hepatoprotective effects of pycnogenol in a rat model of non-alcoholic steatohepatitis. Phytother Res. 2012;26:1572-4.. (In a rat model of nonalcoholic steatohepatitis induced by a methione-choline deficient diet, concurrent treatment with pycnogenol [derived from pine bark] reduced the increase in hepatic fat, triglycerides, and fibrosis and serum ALT elevations, but by small amounts). 22294490
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention pine bark). 22928722
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention pine bark). 23121117
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of pine bark). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to pine bark). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists pine bark as one of 15 ingredients of a single case of suspected supplement induced liver injury).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish Drug-Induced Liver Injury Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of pine bark). 29307848
Malekahmadi M, Moradi Moghaddam O, Firouzi S, Daryabeygi-Khotbehsara R, Shariful Islam SM, Norouzy A, et al. Effects of pycnogenol on cardiometabolic health: A systematic review and meta-analysis of randomized controlled trials. Pharmacol Res. 2019;150:104472.. (In a systematic review of 24 controlled trials of pycnogenol with 1594 patients for effects on cardiometabolic factors, fasting blood glucose changed by -5.8 mg/dL, HgA1c by -0.3%, systolic blood pressure by -2.5 mmHg, LDL levels by -7 mg/dL, and body weight by -0.6 kg, while serum ALT and AST levels did not change). 31585179
Robertson NU, Schoonees A, Brand A, Visser J. Pine bark (Pinus spp.) extract for treating chronic disorders. Cochrane Database Syst Rev. 2020;9:CD008294.. (Cochrane review of the efficacy of pine bark extracts for treating various chronic disorders identified 27 randomized controlled trials [1641 patients] in 10 different chronic disorders concluded that “no definitive conclusions regarding the efficacy or safety of pine bark supplements are possible”). 32990945
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; pine bark is not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3]; pine bark is not mentioned). 33434654
Belcaro G, Cesarone MR, Hu S, Hosoi M, Ledda A, Feragalli B, Saggino A, et al. Pycnogenol® supplementation alleviates symptoms of Parkinson's disease with mild cognitive impairment. J Neurosurg Sci. 2022;66:371-377.. (Among 79 adults with Parkinson disease and mild cognitive impairment treated with pine bark extract [Pycnogenol: 150 mg] or placebo once daily for 8 weeks, symptoms of tremor, bradykinesia and cognitive impairments were improved with treatment and “no side effects of supplementation were observed”). 36153882
Ferguson JJA, Oldmeadow C, Bentley D, Garg ML. Antioxidant effects of a polyphenol-rich dietary supplement incorporating pinus massoniana bark extract in healthy older adults: a two-arm, parallel group, randomized placebo-controlled trial. Antioxidants (Basel). 2022;11:1560.. (Among 60 healthy older adults treated with a Chinese pine bark extract [Pinus massoniana: 1322 mg] or placebo once daily for 12 weeks, plasma antioxidant and anti-inflammatory markers improved with the extract suggesting that it might be beneficial in conditions with heighted oxidative stress such as osteoarthritis, diabetes, and hypertension). 36009279
Cai C, Zeng B, Lin L, Zheng M, Burki C, Grether-Beck S, Krutmann J. An oral French maritime pine bark extract improves hair density in menopausal women: A randomized, placebo-controlled, double blind intervention study. Health Sci Rep. 2023;6:e1045.. (Among 63 Han Chinese menopausal women with hair loss treated with French maritime pine bark extract [Pycnogenol: 50 mg] or placebo three times daily for 6 months, hair density increased slightly with pine bark extract but not placebo and “adverse events were not observed”). 36620515
Nieman KM, Zhu Y, Tucker M, Koecher K. The role of dietary ingredients in mental energy - a scoping review of randomized controlled trials. J Am Nutr Assoc. 2023:1-16. PMID: . (Review of literature on 18 dietary ingredients purported to increase mental energy identified 101 studies [on 16 ingredients] among which ashwagandha, chamomile, dark chocolate, ginseng, lavender, green tea, lion’s mane, maca, turmeric and valerian were said to be “promising”; pine bark was not reviewed). 37162192
Hersant H, He S, Maliha P, Grossberg G. Over the counter supplements for memory: a review of available evidence. CNS Drugs. 2023;37:797-817.. (Analysis of 103 supplements sold as improving memory identified 18 common ingredients, and a review of controlled trials of these compounds found some evidence for effects of ashwagandha, choline, curami, ginger, lion’s mane, polyphenols [but not specifically pine bark], phosphatidylserine, and turmeric but no compelling evidence for use of coenzyme Q, theanine, omega 3 fatty acids, or vitamins B6, B9 and B12; mentions that more than a billion US dollars are spent on supplements for improving cognition yearly). 37603263
Weichmann F, Rohdewald P. Pycnogenol® French maritime pine bark extract in randomized, double-blind, placebo-controlled human clinical studies. Front Nutr. 2024;11:1389374.. (Review of 39 randomized controlled trials of French maritime pine bark suggested that it was beneficial for cardiovascular health, venous insufficiency, cognition, joint health, oral health, and sports performance; no discussion of adverse events or mention of ALT elevations or hepatotoxicity). 38757130
Mohammadi S, Fulop T, Khalil A, Ebrahimi S, Hasani M, Ziaei S, Farsi F, et al. Does supplementation with pine bark extract improve cardiometabolic risk factors? A systematic review and meta-analysis. BMC Complement Med Ther. 2025;25:71.. (Analysis of 27 randomized controlled trials [in 1685 patients] of the effects of 2 to 24 weeks of pine bark extract on cardiometabolic risk factors found that the product reduced systolic [-2.3 mmHg] and diastolic [--2.6 mmHg] blood pressure as well as fasting blood sugar [-6.2 mg/dL], HbA1c [-0.3%], body weight [-1.4 kg], and LDL cholesterol [-5.1 mg/dL] compared to placebo; no mention of adverse events, ALT elevations, or hepatotoxicity). 39987124
Gunnarsdottir SH, Rehrl J, Sepperer T, Haretzmüller L, Sesink D, Löwenstein K, Gadermayr M, et al. Leveraging crude extracts from European tree bark to combat oxidative stress, enhance wound healing, and inhibit pathogenic bacterial growth. Sci Rep. 2025;15:21340.. (Analysis of similar extracts of bark from 6 European trees [alder, beech, birch, bird cherry, oak and pine – Pinus sylvestris] demonstrated variable concentrations of total phenolic content, as well as in antioxidant, antibacterial, and wound healing activity). 40596045
Li E, Maunder A, Liu J, Pandey C, Cave A, O'Fee A, Ee C. The efficacy and safety of herbal medicines for glycemic control and insulin resistance in individuals with type 2 diabetes: an umbrella review. BMC Complement Med Ther. 2025;25:341.. (Review of meta-analyses and systematic reviews of herbal medicines for their effects on glycemic control and insulin resistance concluded that evidence supports the use of ginger and turmeric and reported that the pine bark extract Pycnogenol had minimal effects on HbA1c and fasting blood glucose levels and had no reported serious adverse events). 41029669
Kermanshah A, Master S, Kaceli T, Bedi A, Kalaydjian G. Rhabdomyolysis associated with excess pycnogenol (maritime pine bark extract): a case report. Cureus. 2025;17:e93956.. (35 year old man developed muscle pain and marked elevations in serum creatine kinase [CK] two days after moving furniture and while taking a more than recommended but unknown dose of maritime pine bark [Pycnogenol] initial CK was 154,112 U/L, ALT 597 U/L, AST 2,357 U/L and bilirubin 1.5 mg/dL with improvement in symptoms and blood test results within days of discontinuing the herbal product [after 6 days, CK 7,874 U/L, ALK 468 U/L, AST 252 U/L and bilirubin 0.9 mg/dL]). 41200632

## OTHER REFERENCE LINKS

1. Recent References on Pine bark: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=pine+bark+extract)

2. Trials on Pine bark: from ClinicalTrials.gov (https://clinicaltrials.gov/study/NCT00425945?cond=pine%20bark&rank=1)